# Proguanil

## OVERVIEW

### Introduction

Proguanil is a biguanide derivative which is active against several protozoal species and is used in combination with atovaquone and chloroquine for the prevention and therapy of malaria. Proguanil has not been evaluated extensively as a single agent, but the combinations of proguanil with atovaquone or chloroquine have been used to treat malaria and have been linked to serum enzyme elevations during therapy and rare instances of clinically apparent acute liver injury.

### Background

Proguanil (proe gwahn' il) is a biguanide which is metabolized by the liver to cycloguanil which has potent antimalarial activity. Cycloguanil appears to act by inhibition of plasmodial dihydrofolate reductase-thymidine synthetase and thereby interfering with folate metabolism and DNA synthesis in a manner somewhat similar to pyrimethamine. In contrast, atovaquone is a naphthoquinone that acts by binding to the protozoal or parasitic DNA and preventing DNA and RNA production and subsequent protein synthesis. The two agents are synergistic in combination and demonstrate no cross resistance. The combination of atovaquone and proguanil has been extensively evaluated and was approved in the United States in 2000 for the prevention and treatment of malaria, particularly for drug resistant P. falciparum infection. This combination is available in tablets that contain 250 mg of atovaquone and 100 mg of proguanil in several generic forms and under the brand name Malarone. The recommended therapeutic regimen is four tablets daily for 3 days and one tablet daily for prophylaxis. Combinations of proguanil with chloroquine have also been used in both treatment and prevention of malaria, but not in the United States. Specific and detailed recommendations on the therapy and prevention of malaria are available at: http://www.cdc.gov/malaria/. Common side effects of atovaquone/proguanil include diarrhea, anorexia, nausea, vomiting, abdominal discomfort, headache, dizziness, vivid dreams, insomnia and oral ulcers.

### Hepatotoxicity

The combination of atovaquone and proguanil has been associated with transient and minor serum aminotransferase elevations in a small proportion of patients. More importantly, there have been rare reports of idiosyncratic acute liver injury due in patients on atovaquone/ proguanil but the number of cases has been too few to define a typical clinical course. In one reported case, the onset of injury was after 3 weeks and presentation was with fatigue and jaundice and a cholestatic pattern of serum enzyme elevations. The injury resolved within 2 months of stopping the medication (Case 1). In another case report of chloroquine and proguanil, liver injury arose within days of starting the combination and the pattern of serum enzyme elevations was mixed. In both cases, allergic features were minimal and autoantibodies were not present. In both cases, combination therapy was used and either agent may have been the cause of the injury. Atovaquone and proguanil have also been linked to rare instances of Stevens Johnson syndrome which is often accompanied by mild liver injury or liver enzyme elevations.

Likelihood score: E* (unproven but sometimes suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which proguanil might cause liver injury is unknown. Proguanil is extensively metabolized by the liver. A toxic or immunologic reaction to an intermediate metabolite may underlie hepatotoxicity.

### Outcome and Management

There does not seem to be cross reactivity to hepatic injury among the various antimalarial agents and switching to other drug can be done.

Drug Class: Antimalarial Agents

## CASE REPORT

### Case 1. Cholestatic hepatitis after course of atovaquone/proguanil for malaria prophylaxis.

[Modified from: Grieshaber M, Lämmli J, Marcus L. Acute hepatitis and atovaquone/proguanil. J Travel Med 2005; 12: 289-90. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16256055)]

A 31 year old man developed jaundice and abdominal pain a few days after a 25 day course of atovaquone (250 mg) and proguanil (100 mg) for malaria prophylaxis during travel. Other symptoms included poor appetite, itching, fatigue and dark urine. He had no previous history of liver disease or exposures to hepatitis and did not abuse alcohol. On examination, he had mild fever (37.5 ^o^C) and was jaundiced. There was no mention of rash or eosinophilia. Serum bilirubin was mildly elevated at 2.9 mg/dL and both ALT and alkaline phosphatase levels were prominently increased (Table). Tests for viral hepatitis A, B, C and E were negative as were autoantibody markers. MRI of the abdomen showed a normal appearing liver and biliary system. A liver biopsy was not done. His symptoms gradually improved and serum enzyme abnormalities eventually resolved approximately 8 weeks after initial presentation.

#### Key Points

Medication: | Atovaquone and proguanil
Pattern: | Cholestatic (R=1.7)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 25 days
Recovery: | 8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
4 weeks | 1 week | 320 | 445 | 2.9 | LDH 610 U/L
| 2 weeks | 330 | 410 | 2.2
| 3 weeks | 710 | 330 | 0.6
| 4 weeks | 310 | 240 | 0.5
| 5 weeks | 280 | 190 | 0.5
| 6 weeks | 75 | 115 | 0.5
| 7 weeks | 60 | 110 | 0.5
11 weeks | 8 weeks | 25 | 105 | 0.5
Normal Values | | <40 | <92 | <1.2

* Estimated from Figure 1.

#### Comment

A case of cholestatic hepatitis typical of drug induced liver injury, and the only medications being used were atovaquone and proguanil, either of which may have been the cause. The somewhat delayed decline in serum enzymes is typical of cholestatic forms of drug induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Proguanil – Generic, Malarone® (with Atovaquone), Paludrine®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Proguanil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Proguanil | 500-92-5 | C11-H16-Cl-N5 | Chemical Structure for Proguanil

## ANNOTATED BIBLIOGRAPHY

References updated: 03 February 2017

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; proguanil is not discussed).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Chemotherapy of malaria.l In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1383-418. (Textbook of pharmacology and therapeutics).
Fogh S, Schapira A, Bygbjerg IC, Jepsen S, Mordhorst CH, Kuijlen K, Ravn P, et al. Malaria chemoprophylaxis in travellers to east Africa: a comparative prospective study of chloroquine plus proguanil with chloroquine plus sulfadoxine-pyrimethamine. Br Med J (Clin Res Ed) 1988; 296: 820-2. (Controlled trial of chloroquine with proguanil vs sulfadoxine-pyrimethamine is 767 travelers to Africa; similar efficacy and side effects; no mention of hepatic adverse events). 3130927
Barrett PJ, Emmins PD, Clarke PD, Bradley DJ. Comparison of adverse events associated with the use of mefloquine and combination of chloroquine and proguanil as antimalarial prophylaxis: a postal and telephone survey of travelers. BMJ 1996; 313: 525-8. (Mail questionnaire of 3851 British travelers taking either mefloquine or chloroquine/proguanil for malaria prophylaxis; the rate of side effects was similar [~41%], no mention of hepatic adverse events). 8789977
Høgh B, Clarke PD, Camus D, Nothdurft HD, Overbosch D, Günther M, Joubert I, et al.; Malarone International Study Team. Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in non-immune travelers: a randomised, double-blind study. Malarone International Study Team. Lancet 2000; 356: 1888-94. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 1008 travelers; efficacy was similar, but gastrointestinal upset was more common with chloroquine [20% vs 12%]; among 180 with laboratory testing “No clinically important laboratory abnormalities were identified”). 11130385
Overbosch D, Schilthuis H, Bienzle U, Behrens RH, Kain KC, Clarke PD, Toovey S, et al. Malarone International Study Team. Atovaquone-proguanil versus mefloquine for malaria prophylaxis in nonimmune travelers: results from a randomized, double-blind study. Clin Infect Dis 2001; 33: 1015-21. (Controlled trial of atovaquone-proguanil vs mefloquine of malaria prophylaxis in 483 travelers; similar efficacy [100%], but neuropsychiatric side effects were more common with mefloquine [29% vs 14%] including insomnia, anxiety, vivid dreams, dizziness and trouble concentrating; no mention of liver injury and ALT levels were not monitored). 11528574
Taylor WR, White NJ. Antimalarial drug toxicity: a review. Drug Saf 2004; 27: 25-61. (Review of the toxicities and side effects of antimalarials; atovaquone/proguanil can cause minor ALT elevations, but clinically apparent liver injury was not mentioned). 14720085
Camus D, Djossou F, Schilthuis HJ, Høgh B, Dutoit E, Malvy D, Roskell NS, et al.; International Malarone Study Team. Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in nonimmune pediatric travelers: results of an international, randomized, open-label study. Clin Infect Dis 2004; 38: 1716-23. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 221 children; efficacy was similar [100%], but side effects slightly more with chloroquine [mostly gastrointestinal]; no mention of liver disease or ALT elevations). 15227617
Grieshaber M, Lämmli J, Marcus L. Acute hepatitis and atovaquone/proguanil. J Travel Med 2005; 12: 289-90. (31 year old man developed jaundice and abdominal pain 25 days after starting atovaquone/proguanil prophylaxis [bilirubin 2.9 mg/dL, ALT 320 U/L, Alk P 445 U/L], resolving slowly within 8 weeks of stopping: Case 1). 16256055
Patel SN, Kain KC. Atovaquone/proguanil for the prophylaxis and treatment of malaria. Expert Rev Anti Infect Ther 2005; 3: 849-61. (Review of chemistry, clinical results and safety of atovaquone/proguanil; well tolerated and ALT elevations not discussed). 16307498
Wielgo-Polanin R, Lagarce L, Gautron E, Diquet B, Lainé-Cessac P. Hepatotoxicity associated with the use of a fixed combination of chloroquine and proguanil. Int J Antimicrob Agents 2005; 26: 176-8. (50 year old woman developed jaundice 4 days after starting chloroquine/proguanil for prophylaxis [bilirubin 3.6 mg/dL, ALT 600 U/L, Alk P 744 U/L], resolving within 1 month of stopping; patient had a history of previous exposures to both agents). 16009537
Askling HH, Bruneel F, Burchard G, Castelli F, Chiodini PL, Grobusch MP, Lopez-Vélez R, Paul M, et al; European Society for Clinical Microbiology and Infectious Diseases Study Group on Clinical Parasitology. Management of imported malaria in Europe. Malar J 2012;11: 328. (Recommendations on treatment of malaria from a European panel; atovaquone-proguanil is a first line treatment for uncomplicated P. falciparum malaria; ALT elevations and hepatotoxicity are not mentioned). 22985344
Kimura M, Koga M, Kikuchi T, Miura T, Maruyama H. Efficacy and safety of atovaquone-proguanil in treating imported malaria in Japan: the second report from the research group. Parasitol Int 2012; 61: 466-9. (30 cases of P. falciparum or vivax malaria in Japan were treated successfully with atovaquone-proguanil; one patient with P. falciparum had abnormal liver tests [bilirubin 2.0 mg/dL, ALT 294 U/L] with thrombocytopenia [48,000/μL] that resolved within 4 weeks of treatment). 22484597
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an antimalarial agent). 24552865
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period [2010 and 2011], but none were attributed to an antimalarial agent). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an antimalarial agentl). 25754159
Advice for travelers. Treat Guidel Med Lett 2015: 57 (1466): 52-8. (Concise guidelines on prevention of malaria in travelers indicates that atovaquone-proguanil taken once daily is an effective prophylaxis against choloroquine resistant Plasmodium species, "...generally the best tolerated prophylactic, but it can cause headache, insomnia, GI disturbances and mouth ulcers, and is expensive. Single case reports of Stevens Johnson syndrome and hepatitis have been published"). 25853663

## OTHER REFERENCE LINKS

1. Recent References on Proguanil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=proguanil+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Proguanil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=proguanil)